# Certolizumab Pegol

## OVERVIEW

### Introduction

Certolizumab pegol is a Fab fragment of a monoclonal antibody to human tumor necrosis factor alpha (TNFα) conjugated with polyethylene glycol (pegol) which has potent antiinflammatory activity and is used in the therapy of severe rheumatoid arthritis and inflammatory bowel disease. Certolizumab pegol has had limited use and has yet to be specifically linked to instances of idiosyncratic acute liver injury or reactivation of hepatitis B, but is likely to cause similar hepatic injury to what has been described for other TNFα antagonists such as infliximab and adalimumab.

### Background

Certolizumab (ser" toe liz' ue mab) pegol is a Fab fragment of a humanized recombinant monoclonal antibody to TNFα conjugated to polyethylene glycol (pegol). The monoclonal antibody fragment binds avidly to serum and tissue bound TNFα causing its inactivation and degradation. Inhibition of TNFα activity leads to modulation of the inflammatory and pain pathways activated by this cytokine. The polyethylene glycol alters its pharmacokinetics, prolonging its half-life, and allowing for every 4 week administration. Certolizumab pegol was approved in the United States in 2008 for use in Crohn disease and its indications were subsequently extended to rheumatoid arthritis, juvenile idiopathic arthritis, psoriatic arthritis, ankylosing spondylitis and plaque psoriasis. Certolizumab is considered a disease modifying antirheumatic drug (DMARD) and has been shown to improve symptoms as well as joint and cartilage damage in the inflammatory arthritidies. Certolizumab pegol is available as lyophilized powder for reconstitution or in prefilled syringes as 200 mg/1.0 mL under the brand name of Cimzia. The typical dose of certolizumab pegol for Crohn disease is 200 to 400 mg subcutaneously initially and at weeks 2 and 4, followed by 400 mg every 4 weeks or 200 mg every two weeks. Recommendations vary by indication and age. Common side effects include injection site reactions, headache, nausea, abdominal discomfort, diarrhea, skin rash and fever. Uncommon, but potentially severe adverse reactions include bone marrow suppression, severe and opportunistic infections, neurological reactions, heart failure, malignancies including lymphoma, and hypersensitivity reactions. TNF antagonists are also capable of causing immune suppression, which can result in reactivation of microbial infections including tuberculosis and hepatitis B.

### Hepatotoxicity

Certolizumab pegol has been associated with a low rate of serum aminotransferase elevations during therapy, similar to the rate found with placebo therapy. The ALT elevations have been transient, mild and asymptomatic, and have rarely required dose modification. Despite having been available for more than a decade, certolizumab pegol has been linked to only a few cases of clinically apparent liver injury all of which have been mild and self-limited in course. Nevertheless, it is likely that certolizumab pegol, like infliximab and adalimumab, is capable of inducing clinically apparent liver injury that resembles autoimmune hepatitis, which generally arises after at least 3 months of use and is associated with a hepatocellular pattern of serum enzyme elevation and autoantibody formation. Autoimmune hepatitis induced by anti-TNFα blocking agents can be severe and self-sustained and require corticosteroid therapy. Most severe cases of autoimmune-like hepatitis have been linked to infliximab therapy.

Certolizumab, like other TNFα antagonists, can also be expected to cause reactivation of chronic hepatitis B. Reactivation typically occurs in patients who are inactive HBsAg carriers, with normal serum aminotransferase levels and no or only low levels of HBV DNA in serum. The immune suppression caused by the immunomodulatory agent leads to an increase in HBV replication and rise in serum HBV DNA levels. With stopping the immunosuppression (or between cycles of therapy), restoration of immune function leads to an acute immunological response to the heightened viral replication and a flare of hepatitis, that can be severe and can result in hepatic failure and death. Reactivation in patients with anti-HBc without HBsAg (serologic pattern of previous HBV infection) has been reported only rarely in patients treated with anti-TNF antagonists, and is more common after therapy with rituximab and bone marrow transplantation. The anti-TNF inhibitors have little or no effect on hepatitis C virus levels and have been used safely in patients with chronic hepatitis C.

Likelihood score: D (possible rare cause of clinically apparent liver injury as well as reactivation of hepatitis B).

### Mechanism of Injury

The mechanism of liver injury due to certolizumab pegol and other TNFα antagonists is not known, but is likely caused by immune modulation and induction of autoimmunity.

### Outcome and Management

Most published cases of hepatotoxicity due to anti-TNFα agents have been mild and self-limited. Patients who are to start certolizumab pegol therapy should be screened for evidence of hepatitis B, and those with preexisting HBsAg should be offered prophylaxis with an oral antiviral agent such as lamivudine, tenofovir or entecavir. Patients who develop an autoimmune hepatitis-like syndrome during certolizumab therapy may not recover promptly with stopping the TNFα antagonist and may require corticosteroid therapy. In this event, the corticosteroid dose should be kept to a minimum to control the disease and, ultimately, attempts should be made to withdraw immunosuppression (or decrease to levels used before administration of certolizumab). Rechallenge with another TNFα antagonist after hepatotoxicity from certolizumab pegol has not been reported. Although there appears to be little cross reactivity in hepatic injury among the various TNF antagonists, switching agents after clinically apparent liver injury should be done with caution and only with careful monitoring.

Drug Class: Antirheumatic Agents; Gastrointestinal Agents, Inflammatory Bowel Disease Agents

Other Drugs in the Subclass, Tumor Necrosis Factor Antagonists: Adalimumab, Etanercept, Golimumab, Infliximab

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Certolizumab – Cimzia®

DRUG CLASS

Antirheumatic Agents; Gastrointestinal Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=certolizumab)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Certolizumab Pegol | 428863-50-7 | Monoclonal antibody

## ANNOTATED BIBLIOGRAPHY

References updated: 14 February 2026

Abbreviations Used: TNF, tumor necrosis factor alpha; anti-TNF, antibody to TNF; ANA, anti-nuclear antigen; dsDNA, double stranded DNA; HBV, hepatitis B virus; HBsAg, hepatitis B surface antigen; anti-HBs, antibody to HBsAg; anti-HBc, antibody to hepatitis B core antigen; HBeAg, hepatitis B e antigen; anti-HBe, antibody to HBeAg; HCV, hepatitis C virus, anti-HCV, antibody to HCV.

Zimmerman HJ. Drugs used to treat rheumatic and musculospastic disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 517-54. (Expert review of hepatotoxicity published in 1999; no mention of tumor necrosis factor antagonists such as infliximab or certolizumab pegol).
Reuben A. Hepatotoxicity of immunosuppressive drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2011, pp. 569-91. (Review of hepatotoxicity of immunosuppressive agents; "the biological immuno-suppressants are largely free from hepatototixicity, with the exception of the TNF alpha antagonists").
MacNaughton WK, Sharkey KA. Pharmacotherapy of inflammatory bowel disease. In, Brunton LL, Hilal-Dandan R, Knollman KC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 945-54. (Textbook of pharmacology and therapeutics).
Maini R, St Clair EW, Breedveld F, Furst D, Kalden J, Weisman M, Smolen J, et al. Infliximab (chimeric anti-tumour necrosis factor alpha monoclonal antibody) versus placebo in rheumatoid arthritis patients receiving concomitant methotrexate: a randomised phase III trial. ATTRACT Study Group. Lancet 1999; 354: 1932-9. (Controlled trial of infliximab vs placebo for 30 weeks in 428 patients with rheumatoid arthritis receiving methotrexate, found no difference in rates of ALT elevations between the two groups [37% vs 29%] and no cases of clinically apparent liver injury). 10622295
Menghini VV, Arora AS. Infliximab-associated reversible cholestatic liver disease. Mayo Clin Proc 2001; 76: 84-6. (44 year old woman with Crohn disease developed fatigue 19 days after single infusion of infliximab with subsequent jaundice [bilirubin 7.4 rising to 19.2 mg/dL, ALT 149 U/L, Alk P 55 U/L, ANA weakly positive], liver biopsy showing bland cholestasis and abnormalities resolving within 2 months of stopping: Case 1). 11155419
Nathan DM, Angus PW, Gibson PR. Hepatitis B and C virus infections and anti-tumor necrosis factor-. therapy: guidelines for clinical approach. J Gastro Hepatol 2006; 31: 1366-71. (Review and proposed guidelines for use of anti-TNF therapy in patients with underlying chronic viral hepatitis; recommended screening for HBV and HCV, careful monitoring during therapy and prophylaxis or early intervention with lamivudine in HBsAg-positive patients). 16911678
Vassilopoulos D, Calabrese LH. Risks of immunosuppressive therapies including biologic agents in patients with rheumatic diseases and co-existing chronic viral infections. Curr Opin Rheumatol 2007; 19: 619-25. (Review of use of anti-TNF agents in patients with chronic hepatitis B, C and HIV infection). 17917544
Sandborn WJ, Feagan BG, Stoinov S, Honiball PJ, Rutgeerts P, Mason D, Bloomfield R, et al.; PRECISE 1 Study Investigators. Certolizumab pegol for the treatment of Crohn's disease. N Engl J Med 2007; 357: 228-38. (Controlled trial of certolizumab for 26 weeks in 662 adults with Crohn disease; "No clinically significant changes in laboratory values occurred in either study group"; no mention of hepatotoxicity or ALT elevations). 17634458
Domm S, Cinatl J, Mrowietz U. The impact of treatment with tumour necrosis factor-alpha antagonists on the course of chronic viral infections: a review of the literature. Br J Dermatol 2008; 159: 1217-28. (Review of literature on efficacy and safety of TNF antagonists in patients with chronic hepatitis B and C, recommends screening and monitoring). 18945310
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected from 2004 to 2008, 3 were attributed to etanercept, but none to infliximab, adalimumab or certolizumab). 18955056
Li S, Kaur PP, Chan V, Berney S. Use of tumor necrosis factor-alpha(TNF-alpha) antagonists infliximab, etanercept, and adalimumab in patients with concurrent rheumatoid arthritis and hepatitis B or hepatitis C: a retrospective record review of 11 patients. Clin Rheumatol 2009; 28: 787-91. (Retrospective analysis of 11 patients with rheumatoid arthritis and either hepatitis B [n=3] or C [n=8] during 3 to 60 months anti-TNF therapy, 3 had transient minimal ALT elevations [peak levels 51, 73 and 51 U/L], without symptoms or jaundice). 19291350
Shao LM, Chen MY, Cai JT. Meta-analysis: the efficacy and safety of certolizumab pegol in Crohn's disease. Aliment Pharmacol Ther 2009; 29: 605-14. (Metaanalysis of safety in 3 controlled trials of certolizumab in 1313 patients with Crohn disease; no increase in serious adverse events except for infections, but no specific data on rates of ALT elevation or liver injury provided). 19183161
Smolen J, Landewé RB, Mease P, Brzezicki J, Mason D, Luijtens K, van Vollenhoven RF, et al. Efficacy and safety of certolizumab pegol plus methotrexate in active rheumatoid arthritis: the RAPID 2 study. A randomised controlled trial. Ann Rheum Dis 2009; 68: 797-804. (Controlled trial of methotrexate with or without certolizumab in 619 patients with rheumatoid arthritis; ALT elevations occurred in 5% of patients on methotrexate alone vs 2% on the combination; 5 cases of tuberculosis on certolizumab, but no mention of clinically apparent liver injury). 19015207
Shale MJ, Seow CH, Coffin CS, Kaplan GG, Panaccione R, Ghosh S. Review article: chronic viral infection in the anti-tumour necrosis factor therapy era in inflammatory bowel disease. Aliment Pharmacol Ther 2010; 31: 20-34. (Extensive review of literature on effects of anti-TNF therapies on underlying chronic hepatitis B and C; among 28 HBV-infected patients, reactivation was common in those not on antiviral therapy, more frequent with monoclonal antibodies than etanercept; among 110 HCV-infected patients, little evidence of worsening of disease and in some instances a decrease in HCV RNA levels). 19681818
Smith LS, Nelson M, Dolder CR. Certolizumab pegol: a TNF-{alpha} antagonist for the treatment of moderate-to-severe Crohn's disease. Ann Pharmacother 2010; 44: 333-42. (Review of structure, mechanism of action, pharmacology, safety and efficacy of certolizumab focusing upon Crohn disease; no mention of liver injury or ALT elevations). 20118143
Lichtenstein GR, Thomsen O ~O, Schreiber S, Lawrance IC, Hanauer SB, Bloomfield R, Sandborn WJ; Precise 3 Study Investigators. Continuous therapy with certolizumab pegol maintains remission of patients with Crohn's disease for up to 18 months. Clin Gastroenterol Hepatol 2010; 8: 600-9. (Among 241 patients with Crohn disease continued on certolizumab for up to 80 weeks, 2 patients developed tuberculosis, 1 a lupus-like syndrome, 16 [11%] ANA and 4 [2%] anti-dsDNA reactivity; no mention of liver injury or ALT elevations). 20117244
Sokolove J, Strand V, Greenberg JD, Curtis JR, Kavanaugh A, Kremer JM, Anofrei A, et al.; CORRONA Investigators. Risk of elevated liver enzymes associated with TNF inhibitor utilisation in patients with rheumatoid arthritis. Ann Rheum Dis 2010; 69: 1612-7. (Retrospective analysis of ALT and AST elevations among 6861 patients with rheumatoid arthritis enrolled in a North American database receiving TNF inhibitors followed for an average of 1.5 years with ~1.7 determinations yearly; any elevation of ALT or AST occurred in 5.4% of visits, >2 times ULN in 0.6%, >5 times ULN in 0.1%; rates slightly higher for those on infliximab or when combined with methotrexate and leflunomide). 20448284
Khokhar OS, Lewis JH. Hepatotoxicity of agents used in the management of inflammatory bowel disease. Dig Dis 2010; 28: 508-18. (Review of the hepatotoxicity of drugs used to treat inflammatory bowel disease focusing upon sulfasalazine, thiopurines, TNF inhibitors, and methotrexate). 20926880
Carroll MB, Forgione MA. Use of tumor necrosis factor alpha inhibitors in hepatitis B surface antigen-positive patients: a literature review and potential mechanisms of action. Clin Rheumatol 2010; 29: 1021-9. (Review of literature on anti-TNF therapy in patients with hepatitis B identified 35 cases, 7 cases of reactivation occurred, including 7 of 17 on infliximab but none of 12 on etanercept or 6 on adalimumab; 18 received lamivudine, but only 7 as prophylaxis). 20556450
Pérez-Alvarez R, Díaz-Lagares C, García-Hernández F, Lopez-Roses L, Brito-Zerón P, Pérez-de-Lis M, Retamozo S, et al.; BIOGEAS Study Group. Hepatitis B virus (HBV) reactivation in patients receiving tumor necrosis factor (TNF)-targeted therapy: analysis of 257 cases. Medicine (Baltimore) 2011; 90: 359-71. (Systematic review of literature identified 257 patients with preexisting HBV markers who received anti-TNF therapy, reactivation occurred in 39% of 89 patients with HBsAg [5 had acute liver failure, 4 died], but only 5% of 168 with anti-HBc without HBsAg [1 died]; lamivudine prophylaxis decreased, but did not eliminate reactivation [62% vs 23% in HBsAg carriers). 22033451
Brunasso AM, Puntoni M, Gulia A, Massone C. Safety of anti-tumour necrosis factor agents in patients with chronic hepatitis C infection: a systematic review. Rheumatology (Oxford) 2011; 50: 1700-11. (Systematic review of literature identified 153 patients with chronic hepatitis C treated with anti-TNF agents, mostly etanercept, with only 1 with definite worsening of disease on treatment). 21690185
Vassilopoulos D, Calabrese LH. Management of rheumatic disease with comorbid HBV or HCV infection. Nat Rev Rheumatol 2012; 8: 348-57. (Clinical review of chronic hepatitis B and C and the implications in patients with rheumatic disorders with interpretation of virologic markers and recommendations for screening and prophylaxis against HBV during immunosuppressive therapy) 22565315
Aaltonen KJ, Virkki LM, Malmivaara A, Konttinen YT, Nordström DC, Blom M. Systematic review and meta-analysis of the efficacy and safety of existing TNF blocking agents in treatment of rheumatoid arthritis. PLoS One 2012; 7: e30275. (Systematic review of 26 controlled trials of anti-TNF agents for rheumatoid arthritis found similar rates of efficacy with different agents, but slightly lower rates of adverse events with etanercept, as measured by rates of discontinuation for adverse events [risk ratio=0.71]). 22272322
Ghabril M, Bonkovsky HL, Kum C, Davern T, Hayashi PH, Kleiner DE, Serrano J, et al.; US Drug-Induced Liver Injury Network. Liver injury from tumor necrosis factor-α antagonists: analysis of thirty-four cases. Clin Gastroenterol Hepato 2013; 11: 558-64. (Description of 6 cases of acute liver injury due to TNF antagonists from the US included 5 women [83%], ages 28 to 54 years, onset after 2-52 weeks of treatment with infliximab [n=3], etanercept [n=2] or adalimumab [n=1] but none with golimumab or certolizumab pegol; peak bilirubin ranged from 1.5 to 34.2 mg/dL, ALT 384 to 1687 U/L, Alk P 83 to 1311 U/L, 3 patients were positive for ANA, 5 were treated with corticosteroids, but all ultimately recovered). 23333219
Motaparthi K, Stanisic V, Van Voorhees AS, Lebwohl MG, Hsu S. From the Medical Board of the National Psoriasis Foundation: Recommendations for screening for hepatitis B infection prior to initiating anti-tumor necrosis factor-alfa inhibitors or other immunosuppressive agents in patients with psoriasis. J Am Acad Dermatol 2013 Nov 9. [Epub ahead of print] 24220724 (Recommendations for screening and monitoring for hepatitis B in patients with psoriasis treated with anti-TNF agents). 24220724
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, the most common implicated agents being nimesulide [n=53: 30%], cyproterone [n=18], nitrofurantoin [n=17], antituberculosis drugs [n=13] and flutamide [n=12: 7%]; but none were attributed to a TNF antagonist). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, 6 cases were attributed to TNF antagonists: 1 to adalimumab, 2 etanercept and 3 infliximab, but none to certolizumab pegol or golimumab). 25754159
Petríková J, Jarčuška P, Svajdler M, Pella D, Macejová Z. Autoimmune hepatitis triggered by adalimumab and allergic reactions after various anti-TNFα therapy agents in a patient with rheumatoid arthritis. Isr Med Assoc J 2015; 17: 256-8. (33 year old woman with rheumatoid arthritis developed fatigue after 3 doses of adalimumab [bilirubin not given, ALT 888 U/L, Alk P 348 U/L, ANA positive], biopsy showing interface hepatitis, resolving with prednisolone; later having allergic reactions to etanercept and certolizumab, but responding to anakinra). 26040057
Chiu YM, Tang CH, Hung ST, Yang YW, Fang CH, Lin HY. A real-world risk analysis of biological treatment (adalimumab and etanercept) in a country with a high prevalence of tuberculosis and chronic liver disease: a nationwide population-based study. Scand J Rheumatol 2017:46:236-40. 27766916 (Nationwide population-based data on use of adalimumab [n=4049] and etanercept [n=5117] between 2007 and 2011, identified higher rates of serious hepatic events for adalimumab vs etanercept [0.75 vs 0.39 per 100 person years] as well as higher rates of tuberculosis [1.62 vs 0.57 per 100 person-years]).
Parisi I, O'Beirne J, Rossi RE, Tsochatzis E, Manousou P, Theocharidou E, et al. Elevated liver enzymes in inflammatory bowel disease: the role and safety of infliximab. Eur J Gastroenterol Hepatol 2016; 28: 786-91. (In a retrospective analysis of liver test abnormalities in 305 patients with inflammatory bowel disease followed between 2008 and 2013, ALT elevations arose in 36% of patients, only slightly more commonly in those on infliximab [n=176: 39%] than on other agents [n=129: 33%], most elevations being mild and resolving spontaneously). 27015138
Forker R, Escher M, Stange EF. Colitis ulcerosa und fulminantes Leberversagen bei einer 20‑jährigen Patientin [A 20-year-old woman with ulcerative colitis and acute liver failure]. Internist (Berl). 2017;58:982-989. German. PMID: 28271269 (20 year old woman with refractory ulcerative colitis developed fatigue and marked serum enzyme elevations 4 days after an initial infusion of infliximab [bilirubin 1.8 mg/dL, ALT 2685 U/L, GGT 222 U/L, INR 11.0] which fell rapidly with supportive therapy).
Koller T, Galambosova M, Filakovska S, Kubincova M, Hlavaty T, Toth J, Krajcovicova A, et al. Drug-induced liver injury in inflammatory bowel disease: 1-year prospective observational study. World J Gastroenterol. 2017;23:4102-4111. (Among 251 patients with inflammatory bowel disease enrolled in a prospective study with liver test monitoring every 3 months, 66 [22%] had ALT elevations that were usually transient and mild, most commonly in those on infliximab, only 16 patients had ALT elevations above twice normal, only 4 of which persisted, none with symptoms or bilirubin elevations, and all with other possible causes such as alcohol use or obesity). 28652663
Ricciuto A, Kamath BM, Walters TD, Frost K, Carman N, Church PC, Ling SC, et al. New onset autoimmune hepatitis during anti-tumor necrosis factor-alpha treatment in children. J Pediatr. 2018;194:128-135.e1. (17 year old girl with Crohn disease developed abdominal pain 23 weeks [6 infusions] after starting infliximab [bilirubin not given, ALT 359 U/L, GGT 45 U/L, ALT 1:640] resolving after discontinuation; and review of 659 children treated for inflammatory bowel disease with infliximab at their institution between 2000 and 2015, found that ALT elevations arose in 8% but none developed jaundice or clinically apparent liver injury or required drug discontinuation for liver injury). 29274889
Kok B, Lester ELW, Lee WM, Hanje AJ, Stravitz RT, Girgis S, Patel V, et al; United States Acute Liver Failure Study Group. Acute liver failure from tumor necrosis factor-α antagonists: report of four cases and literature review. Dig Dis Sci. 2018;63:1654-1666. (Among more than 2500 cases of acute liver failure enrolled in a prospective US database between 1998 and 2014, 4 were attributed to infliximab induced liver injury, 3 women, 1 man, ages 34 to 59 years, with latency of 1 to 12 months, with hepatocellular pattern of enzyme elevations, 3 with ANA positivity resulting in liver transplant in 3 and death in one; none were attributed to other TNF antagonists). 29564668
Drugs for psoriatic arthritis. Med Lett Drugs Ther. 2019;61(1588):203-210. (Concise review of the mechanism of action, efficacy, safety, and costs of drugs for psoriatic arthritis, mentions that five TNF antagonists are approved for this condition and appear to have similar efficacy and their adverse events include reactivation of hepatitis B; does not mention the risk of hepatotoxicity). 31999665
Drugs for rheumatoid arthritis. Med Lett Drugs Ther. 2021;63(1637):177-184. (Concise review of the mechanism of action, efficacy, safety, and costs of drugs for rheumatoid arthritis, mentions that five TNF antagonists are indicated for rheumatoid arthritis if maximal tolerated doses of methotrexate are not adequately effective; description of adverse events mentions reactivation of hepatitis B and induction of autoimmune conditions but not hepatotoxicity). 35085210
Björnsson HK, Gudbjornsson B, Björnsson ES. Infliximab-induced liver injury: clinical phenotypes, autoimmunity and the role of corticosteroid treatment. J Hepatol. 2022;76:86-92. (Among 36 Icelandic patients who developed elevated enzymes after starting infliximab therapy between 2009 and 2020, median age was 46 years, 78% were women, mostly with rheumatologic diseases, latency to onset median of 110 days, usually with moderate hepatocellular enzyme elevations and minimal increases in Alk P and bilirubin, only 4 with jaundice, 2 hospitalized, 67% with ANA [half were positive before therapy], infliximab stopped in all but ALT elevations frequently persisted, 17 [47%] were treated with corticosteroids which led to rapid resolution [45 vs 79 days without corticosteroids], and all eventually stopped corticosteroid without relapse even when treated with other TNF antagonists). 34487751
Núñez F P, Quera R, Bay C, Castro F, Mezzano G. Drug-induced liver injury used in the treatment of inflammatory bowel disease. J Crohns Colitis. 2022;16:1168-1176. (Review of the hepatic adverse events that occur with therapies of inflammatory bowel disease such as sulfasalazine, thiopurines, methotrexate, TNF antagonists, newer monoclonal and small molecule inhibitors, and sphingosine-1-phosphate modulators). 35044449
Björnsson ES, Stephens C, Atallah E, Robles-Diaz M, Alvarez-Alvarez I, Gerbes A, Weber S, et al. A new framework for advancing in drug-induced liver injury research. The Prospective European DILI Registry. Liver Int. 2023;43:115-126. (Initial results from the prospective European multi-national drug-induced liver injury registry [UK, Spain, Germany, Switzerland, Portugal, Iceland] describes 246 cases, the most frequent implicated agents being amoxicillin-clavulanate [12%], flucloxacillin [11%] atorvastatin [8%], nivolumab/ipilimumab [8%], infliximab [5%], nitrofurantoin [4.5%], disulfiram [2%], ibuprofen [2%], and HDS products [7.3%]; jaundice in 60% and fatal outcome in 4%; no mention of adalimumab or other TNF antagonists). 35899490
Drugs for inflammatory bowel disease. Med Lett Drugs Ther. 2023;65(1680):105-112. (Concise review of the mechanism of action, efficacy, safety, and costs of drugs for ulcerative colitis and Crohn disease, mentions that the monoclonal antibodies to TNF are effective in induction and maintenance of remissions, infliximab and adalimumab being approved for both forms, certolizumab for ulcerative colitis only and golimumab for Crohn disease only; discussion of adverse events mentions reactivation of hepatitis B and induction of autoimmune conditions but without mention of hepatotoxicity). 37418329
Drugs for plaque psoriasis. Med Lett Drugs Ther. 2024;66(1712):153-160. (Concise review of the mechanism of action, efficacy, safety, and costs of drugs for psoriasis, mentions that four TNF antagonists are approved for moderate-to-severe plaque psoriasis and that adverse events include reactivation of hepatitis B but does not mention hepatotoxicity). 39302348
Bensaghir I, Tahiri L, Farih S, Rkain H, Allali F. Certolizumab-induced liver injury in ankylosing spondylitis: a case report and causality assessment. Cureus. 2024;16:e66569. (34 year old man with ankylosing spondylitis refractory to infliximab therapy developed evidence of mild liver injury 6 months after starting certolizumab [ALT 151 U/L; no mention of bilirubin or Alk P] which resolved within a month after stopping certolizumab). 39258044
Björnsson HK, Sigmundsson HK, Björnsson ES. Severe liver injury due to infliximab therapy and adalimumab. Scand J Gastroenterol. 2025;60:1238-1246. (Review of the literature on cases of severe liver injury attributed to TNF antagonists identified 12 reports of severe acute liver injury due to infliximab but only one due to adalimumab [Hagel 2011] and none due to golimumab or certolizumab pegol). 41086316
Bessone F, Bjornsson ES. Autoimmune-like hepatitis induced by drugs: Still many unanswered questions. World J Hepatol. 2025;17:110946. (Review of the clinical features, causes, diagnosis, and management of drug-induced autoimmune-like hepatitis and comparison to spontaneous autoimmune hepatitis mentions the most common causes as minocycline, nitrofurantoin, hydralazine, methyldopa, infliximab, adalimumab, statins, interferon, and imatinib). 41368109
Peggie E, Shetty S, Johnston M, May C, Oien K, Kohnen G. Certolizumab-associated autoimmune-like hepatitis. BMJ Case Rep. 2025;18:e266955.. (30ish year old woman with psoriasis had a rapid clinical response certolizumab but developed enzyme elevations 10 weeks of therapy with worsening for a month after stopping [bilirubin 0.5 rising to 1.2 mg/dL, ALT 230 to 1788 U/L, Alk P 81 to 237 U/L, ANA 1:640, IgG 11.7 mg/dL] but ultimately resolving without corticosteroid therapy by 20 weeks). 41423287
Chen H, Jiang S, Wang J, Zhang A, Zhu L. Hepatobiliary disorders associated with TNF-α inhibitors: a pharmacovigilance analysis of FAERS and JADER. Front Immunol. 2026;16:1739631. (Analysis of the US FDA adverse event reporting system [FAERS] between 2004 and 2025 for TNF antagonists found 19,083 reports of hepatobiliary events, 9501 for adalimumab, 3979 infliximab, 3949 etanercept, 1012 certolizumab pegol, and 642 golimumab). 41601665

## OTHER REFERENCE LINKS

1. Recent References on Certolizumab: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Certolizumab/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Certolizumab: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Certolizumab)